# Patisiran

## OVERVIEW

### Introduction

Patisiran is a synthetic small interfering RNA (siRNA) molecule directed against the mRNA of transthyretin that is used to treat adults with the polyneuropathy of transthyretin-mediated amyloidosis. Patisiran has not been linked to serum aminotransferase elevations during therapy or to instances of clinically apparent liver injury with symptoms or jaundice.

### Background

Patisiran (pa” ti sir’ an) is a synthetic, double-stranded, small interfering RNA (siRNA) directed against the mRNA of transthyretin, a serum protein made in the liver whose major function is transport of vitamin A and thyroxine. Rare mutations in the transthyretin gene result in misfolding of the protein and accumulation of large amyloid deposits of transthyretin molecules most prominently in peripheral nerves and the heart. Patients with inherited transthyretin amyloidosis typically present with polyneuropathy or autonomic dysfunction followed by cardiomyopathy which, if untreated, is usually fatal within 5 to 12 years. Patisiran was developed to reduce production of transthyretin (both the wild type and mutant forms) and prevent accumulation of further amyloid deposits. Patisiran is administered intravenously, and uptake by the liver is facilitated by its packaging in lipid nanoparticles (which also protect against ribonuclease digestion). Once taken up by hepatocytes, the siRNA is cleaved into smaller fragments and separated into single strands that bind and silence the mRNA of transthyretin. In animal models, patisiran reduced transthyretin protein levels in blood and mRNA levels in liver. In trials of patisiran in patients with hereditary transthyretin amyloidosis with polyneuropathy, intravenous infusions resulted in rapid and sustained reductions in serum transthyretin levels (averaging ~78%) and significant improvements in neuropathy and quality of life scales compared to placebo therapy. Patisiran was approved for use in the United States in 2018 for adults with transthyretin amyloidosis and polyneuropathy. It is under evaluation for efficacy and safety in patients with cardiomyopathy due to transthyretin amyloidosis. Patisiran is available in a lipid complex solution in single dose vials of 10 mg in 5 mL (2 mg/mL) under the brand name Onpattro. The recommended dose regimen is 0.3 mg/kg (to a maximal dose 30 mg) administered intravenously every 3 weeks. Administration by a health care provider is required as is premedication with corticosteroids, acetaminophen, antihistamines and an H2 blocker. Patisiran is generally well tolerated the most common side effects being injection site reactions. Other potential adverse events include peripheral edema, fatigue, arthralgias, diarrhea and musculoskeletal pains. In preregistration studies, 3% of patisiran treated patients developed anti-drug antibodies, but their presence was not associated with decreased efficacy or safety. Because patisiran reduces serum transthyretin levels, it also reduces serum vitamin A levels and vitamin A supplementation is recommended using doses of the recommended daily allowance.

### Hepatotoxicity

In preregistration trials, patisiran therapy was well tolerated except for infusion reactions. Patients with amyloidosis often have hepatomegaly and mild serum enzyme elevations. Serum aminotransferase elevations arose in approximately 20% of patisiran- vs 10% of placebo-recipients, but the elevations were usually mild (less than 5 times ULN), transient and without accompanying symptoms or jaundice. Since its approval, there have been no published reports of liver injury attributed to patisiran therapy. Thus, patisiran is an unlikely cause of clinically apparent liver injury, although it has had limited widescale clinical use.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The possible cause of hepatic injury from patisiran or other siRNA therapeutics is not known. Patisiran has been linked to mild-to-moderate, transient serum aminotransferase elevations that usually resolve spontaneously without dose modification. The cause of these abnormalities is unknown, but patients with amyloidosis can have hepatomegaly and minor serum enzyme elevations while on no therapy. Alternatively, the serum ALT and AST elevations may relate to the lipid complex used to improve hepatic update of the siRNA. Patisiran, like other RNA therapeutic agents, is metabolized intracellularly by nucleases and is not a substrate of cytochrome P450 enzymes or hepatic transporters.

### Outcome and Management

Patisiran has not been linked to clinically significant liver test abnormalities or to clinically apparent liver injury and regular monitoring of routine liver tests is not recommended. The requirements for intravenous administration and premedication makes management of therapy challenging.

Drug Class: Genetic Disorder Agents, siRNA and Antisense Agents

Other Therapeutic siRNA-based Agents: Givosiran, Inclisiran, Lumasiran, Vutrisiran

Other Drugs for Transthyretin-Mediated Amyloidosis: Acoramidis, Eplontersen, Tafamidis, Vutrisiran

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Patisiran – Onpattro®

DRUG CLASS

Genetic Disorder Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/drugInfo.cfm?setid=e87ec36f-b4b4-49d4-aea4-d4ffb09b0970)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Patisiran | 1420706-45-1 (https://pubchem.ncbi.nlm.nih.gov/substance/350082694) | C412-H480-N148-Na40-O290-P40 | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 25 February 2025

Abbreviations: mRNA, messenger RNA; siRNA, small interfering RNA.

FDA. Patisiran. Multi-Discipline Review. 2018.
https://www.accessdata.fda.gov/drugsatfda_docs/nda/2018/210922Orig1s000MultiR.pdf (The FDA clinical review of patisiran for efficacy and safety reported that ALT elevations arose in 20% of patisiran- vs 10% of placebo-recipients in preregistration controlled trials, but that all elevations were transient, less than 5 times the ULN, and were not associated with jaundice or symptoms; in addition, there were no hepatic serious adverse events or deaths).
Suhr OB, Coelho T, Buades J, Pouget J, Conceicao I, Berk J, Schmidt H, et al. Efficacy and safety of patisiran for familial amyloidotic polyneuropathy: a phase II multi-dose study. Orphanet J Rare Dis. 2015;10:109. (Among 29 patients with hereditary transthyretin amyloidosis with polyneuropathy treated with varying doses regimens of patisiran, there was a rapid marked decline in serum transthyretin levels [averaging -85%] and adverse events were mild-to-moderate, mostly infusion reactions, not requiring discontinuation, and “no clinically significant changes in liver function tests…were recorded”). 26338094
Butler JS, Chan A, Costelha S, Fishman S, Willoughby JL, Borland TD, Milstein S, et al. Preclinical evaluation of RNAi as a treatment for transthyretin-mediated amyloidosis. Amyloid. 2016;23:109-18. (In a murine model of hereditary transthyretin-mediated amyloidosis, patisiran resulted in knock down of transthyretin and dose related regression of amyloid deposits). 27033334
Adams D, Gonzalez-Duarte A, O'Riordan WD, Yang CC, Ueda M, Kristen AV, Tournev I, et al. Patisiran, an RNAi therapeutic, for hereditary transthyretin amyloidosis. N Engl J Med. 2018;379:11-21. (Among 245 patients with hereditary transthyretin amyloidosis treated with patisiran [0.3 mg/kg] or placebo intravenously every 3 weeks for up to 6 months, neuropathy and quality of life scores improved with patisiran therapy and usually worsened with placebo, while adverse event rates were similar in the two groups except for infusion reactions [19% vs 9%] and peripheral edema [30% vs 22%], and there were no “clinically relevant changes in laboratory values” including indicators of liver function). 29972753
Hoy SM. Patisiran: first global approval. Drugs. 2018 Oct;78(15):1625-1631. (Review of the mechanism of action, structure, history of development, clinical efficacy and safety of patisiran shortly after its approval for use in hereditary transthyretin amyloidosis with polyneuropathy, mentions that there were no treatment related serious adverse events; no mention of ALT elevations or hepatotoxicity). 30251172
Setten RL, Rossi JJ, Han SP. The current state and future directions of RNAi-based therapeutics. Nat Rev Drug Discov 2019; 18: 421-46. (Extensive review of gene silencing using RNA interference pathways and the potential of RNAi therapeutics which have promise in many genetic and acquired diseases including transthyretin amyloidosis [transthyretin], HIV infection [CCR5], HBV [HBV mRNA], alpha-1-antitrypsin deficiency [zz A1AT], hypercholesterolemia [PCSK9]). 30846871
Zhang X, Goel V, Attarwala H, Sweetser MT, Clausen VA, Robbie GJ. Patisiran pharmacokinetics, pharmacodynamics, and exposure-response analyses in the phase 3 APOLLO Trial in patients with hereditary transthyretin-mediated (hATTR) amyloidosis. J Clin Pharmacol. 2020;60:37-49. (Pharmacokinetic studies conducted on 145 patients with hereditary transthyretin amyloidosis treated with patisiran for 18 months demonstrated stable drug levels and only 5 subjects developed anti-drug antibodies [3.4%] that had no appreciable effects on drug levels, efficacy or safety). 31322739
Coelho T, Adams D, Conceição I, Waddington-Cruz M, Schmidt HH, Buades J, Campistol J, et al. A phase II, open-label, extension study of long-term patisiran treatment in patients with hereditary transthyretin-mediated (hATTR) amyloidosis. Orphanet J Rare Dis. 2020;15:179. (Among 27 patients with transthyretin amyloidosis participating in a phase 2 trial of patisiran which was then continued for 24 months, improvements in neuropathy and quality of life were sustained and adverse events were generally mild, with no discontinuations for adverse events and no significant changes in liver biochemical test results). 32641071
Adams D, Polydefkis M, González-Duarte A, Wixner J, Kristen AV, Schmidt HH, Berk JL, et al.; patisiran Global OLE study group. Long-term safety and efficacy of patisiran for hereditary transthyretin-mediated amyloidosis with polyneuropathy: 12-month results of an open-label extension study. Lancet Neurol. 2021;20:49-59. (Among 211 patients with hereditary transthyretin amyloidosis and polyneuropathy enrolled in an open label extension study after phase 2 and 3 controlled trials of patisiran, improvements in neuropathy and quality of life scores arose in placebo groups when crossed over to active therapy and were sustained in active treatment groups, and there were “no clinically relevant safety concerns…related to hepatic events”). 33212063
Luigetti M, Servidei S. Patisiran in hereditary transthyretin-mediated amyloidosis. Lancet Neurol. 2021;20:21-23. (Editorial in response to Adams [2021] summarizing results on the efficacy of patisiran in hereditary transthyretin amyloidosis and discussing the uncertainty related to long term therapy and treatment of advanced disease and cardiomyopathy). 33212064
Suzuki Y, Ishihara H. Difference in the lipid nanoparticle technology employed in three approved siRNA (Patisiran) and mRNA (COVID-19 vaccine) drugs. Drug Metab Pharmacokinet. 2021;41:100424. (Description of the lipid components used to create nanoparticles for administration of patisiran, the lipids protecting the RNA against nuclease digestion and allowing uptake by hepatocytes [via the LDL receptor] and release of the siRNA with acidification of the endosomes containing the incorporated patisiran). 34757287
Schmidt HH, Wixner J, Planté-Bordeneuve V, Muñoz-Beamud F, Lladó L, Gillmore JD, Mazzeo A, et al.; Patisiran Post-LT Study Group. Patisiran treatment in patients with hereditary transthyretin-mediated amyloidosis with polyneuropathy after liver transplantation. Am J Transplant. 2022;22:1646-1657. (Among 12 patients with hereditary transthyretin amyloidosis with polyneuropathy who had undergone liver transplant but continued to have neuropathy were treated with patisiran for at least 12 months, neuropathy and autonomic syndrome scores improved while disability and nutrition status were stable; 11 [48%] patients developed ALT elevations that were usually transient and mild, one developed acute rejection and one cholangitis, but all abnormalities resolved despite continued patisiran therapy without dose modification). 35213769
Aimo A, Castiglione V, Rapezzi C, Franzini M, Panichella G, Vergaro G, Gillmore J, et al. RNA-targeting and gene editing therapies for transthyretin amyloidosis. Nat Rev Cardiol. 2022;19(10):655-667. (Extensive review of the molecular basis of hereditary transthyretin amyloidosis and the small molecule and RNA based therapies in current use and in experimental clinical trials, mentions the efficacy and relative safety of patisiran which has not been linked to instances of liver dysfunction). 35322226
Di Stefano V, Fava A, Gentile L, Guaraldi P, Leonardi L, Poli L, Tagliapietra M, et al. Italian real-life experience of patients with hereditary transthyretin amyloidosis treated with patisiran. Pharmgenomics Pers Med. 2022;15:499-514. (Case histories of 9 patients with transthyretin amyloidosis with polyneuropathy who were treated long term with patisiran in “Italian real-life” with clinical improvement and excellent tolerance; no mention of ALT elevations or hepatotoxicity). 35592550
Maurer MS. Overview of current and emerging therapies for amyloid transthyretin cardiomyopathy. Am J Cardiol. 2022;185 Suppl 1:S23-S34. (Review of approaches to therapy of amyloid transthyretin cardiomyopathy including the transthyretin stabilizers [tafamidis, acoramidis] and transthyretin gene silencing or knockdown agents [patisiran, vutrisiran, inotersen, eplontersen, CRISPR-Cas9], no mention of liver related adverse events). 36371281
Ranasinghe P, Addison ML, Dear JW, Webb DJ. Small interfering RNA: Discovery, pharmacology and clinical development–An introductory review. Br J Pharmacol. 2023;180(21):2697-2720. (Review of the history of development, mechanism of action, methods of delivery, clinical efficacy and safety of RNA silencing drugs including lumasiran, givosiran, inclisiran, patisiran and vutrisiran, discusses adverse events from patisiran of injection site reactions, but does not mention hepatotoxicity or ALT elevations). 36250252
Aimo A, Castiglione V, Rapezzi C, Franzini M, Panichella G, Vergaro G, Gillmore J, et al. RNA-targeting and gene editing therapies for transthyretin amyloidosis. Nat Rev Cardiol. 2022;19:655-667. (Review of the molecular approaches to therapy of transthyretin-related amyloidosis including small interfering RNA [siRNA, patisiran, vutrisiran], antisense RNA [inotersen, eplontersen], CRISPR-Cas9 therapy, and molecular stabilization agents [acoramidis, tafamidis], some of which been linked to minor serum aminotransferase elevations during therapy [vutrisiran, eplontersen], but not to clinically apparent liver injury). 35322226
Adams D, Tournev IL, Taylor MS, Coelho T, Planté-Bordeneuve V, Berk JL, González-Duarte A, et al.; HELIOS-A Collaborators. Efficacy and safety of vutrisiran for patients with hereditary transthyretin-mediated amyloidosis with polyneuropathy: a randomized clinical trial. Amyloid. 2023;30:1-9. (Among 164 patients with hereditary transthyretin amyloidosis with polyneuropathy treated with vutrisiran [25 mg subcutaneously every 3 months] or patisiran 0.3 mg/kg intravenously every 3 weeks] for 18 months, vutrisiran was found to be non-inferior to patisiran and more effective than placebo [from an external placebo group] and most adverse events were mild and there were no drug related discontinuations or deaths; no mention of ALT elevations or hepatotoxicity). 35875890
Maurer MS, Kale P, Fontana M, Berk JL, Grogan M, Gustafsson F, Hung RR, et al.; APOLLO-B Trial Investigators. Patisiran treatment in patients with transthyretin cardiac amyloidosis. N Engl J Med. 2023;389(17):1553-1565. (Among 360 patients with transthyretin-mediated amyloidosis and cardiomyopathy treated with patisiran [0.3 mg/kg] or placebo intravenously every 3 weeks for 12 months, decline in 6 minute walk distance was lower with patisiran and cardiomyopathy questionnaire scores improved more with patisiran; while adverse event rates were similar [91% vs 94%], those attributed to the drug were infusion reactions, arthralgia and muscle spasms, and “no clinically relevant changes in laboratory measures (including …liver-function tests…] were observed”). 37888916
Liu Y, Li H, Hu C, Tan L, Yin P, Li Z, Zhou S, Su L. A real-world pharmacovigilance analysis for transthyretin inhibitors: findings from the FDA adverse event reporting database. Front Pharmacol. 2024;15:1368244. (Analysis of the FDA Adverse Event Reporting System [FAES] reports on transthyretin inhibitors made over a 5 year period, found the top 50 events for patisiran included fatigue, asthenia, and falls, but not liver test abnormalities). 38873427
Ruberg FL, Maurer MS. Cardiac amyloidosis due to transthyretin protein: a review. JAMA. 2024;331:778-791. (Review of the pathogenesis, genetics, clinical features, diagnosis, and treatment of transthyretin-mediated amyloidosis cardiomyopathy; no mention of ALT elevations or hepatotoxicity). 38441582
Adams D, Wixner J, Polydefkis M, Berk JL, Conceição IM, Dispenzieri A, Peltier A, et al. Five-year results with patisiran for hereditary transthyretin amyloidosis with polyneuropathy: a randomized clinical trial with open-Label extension. JAMA Neurol. 2025 Jan 13. Epub ahead of print. (Among 212 patients who completed the placebo controlled trial of patisiran for transthyretin amyloid polyneuropathy [Adams 2023] who were then enrolled in an open label extension study, polyneuropathy disability scores remained stable or improved, exposure adjusted survival rate was improved, and no new safety concerns were identified; no mention of ALT elevations or hepatotoxicity). 39804640

## OTHER REFERENCE LINKS

1. Recent References on Patisiran: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Patisiran/AE)%20AND%20Human%5bMH%5d%20AND%20(drug%20induced%20liver%20injury%20OR%20jaundice/CI%20OR%20bile%20duct%20diseases/CI%20OR%20liver/DE%20OR%20liver%20diseases/CI)%20AND%20(%221900%5C%5C1%5C%5C1%22%5bEDat%5d:%222999%5C%5C12%5C%5C31%22%5bEDat%5d))

2. Trials on Patisiran: from ClinicalTrials.gov (https://www.clinicaltrials.gov/ct2/results?term=Patisiran)